# Daratumumab

## OVERVIEW

### Introduction

Daratumumab is a human monoclonal antibody to CD38 which is used in combination with other antineoplastic agents in the therapy of multiple myeloma. Daratumumab has been implicated in instances of transient, mild-to-moderate serum enzyme elevations, but has not been linked to cases of clinically apparent liver injury with jaundice.

### Background

Daratumumab (dar" a toom' ue mab) is human IgG1 monoclonal antibody to CD38, which is a transmembrane glycoprotein that is frequently overexpressed on cancer cells including multiple myeloma cells. The monoclonal antibody binds to the CD38 molecule and triggers cell apoptosis, probably as a result of antibody mediated cytotoxicity. Daratumumab has been evaluated in heavily pretreated patients with refractory multiple myeloma and shown overall response rates of higher than expected. Daratumumab was given accelerated approval in the United States in 2015 for use in multiple myeloma. Current indications are as therapy of patients with refractory multiple myeloma in combination with lenalidomide (or bortezomib) and dexamethasone or as monotherapy in patients who have failed at least three previous regimens. Daratumumab is available as a solution for intravenous infusion in single use vials of 100 mg in 5 mL or 400 mg in 20 mL (20 mg/mL). The recommended dose is 16 mg/kg intravenously every week for 8 to 9 weeks, and then every 2, 3 or 4 weeks based upon indications and other agents being used. Premedication with methylprednisolone is recommended. Side effects are common and can include infusion reactions, bone marrow suppression, fatigue, nausea and vomiting, diarrhea, muscle spasms, back pain, fever, cough, dyspnea, peripheral edema, peripheral neuropathy and upper respiratory infection. Rare, but potentially serious side effects include severe infusion reactions, neutropenia, thrombocytopenia and interference with cross matching and red blood cell antibody screening.

### Hepatotoxicity

In summary analyses of the registration trials of daratumumab for multiple myeloma, 15% of patients developed elevations in ALT during therapy, 13% alkaline phosphatase and 7% bilirubin. The abnormalities were generally mild-to-moderate, transient and asymptomatic. ALT elevations above 5 times the upper limit of normal occurred in less than 1% of patients. In these studies, daratumumab was given with lenalidomide and dexamethasone, and similar rates of liver enzyme elevations occurred with those agents alone without the monoclonal antibody. There were no instances of clinically apparent liver injury with jaundice attributable to daratumumab in these trials and no patient stopped therapy because of hepatic adverse events. Since its approval and more general use, there have been no published reports of clinically apparent liver injury due to daratumumab, and its product label does not list hepatotoxicity as an adverse event.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which daratumumab might cause liver injury is not known. There is no evidence that CD38 is expressed on hepatocytes. Like other monoclonal antibodies, daratumumab is unlikely to have intrinsic hepatotoxicity, is metabolized to smaller peptides or amino acids by many cells, and does not affect the hepatic drug metabolizing enzymes or transporting molecules.

### Outcome and Management

The liver injury attributed to daratumumab has invariably been self-limited and not associated with symptoms or jaundice. There is no information on possible cross sensitivity to the injury among different monoclonal antibodies or therapies directed at epidermal growth factor receptors.

Drug Class: Antineoplastic Agents, Monoclonal Antibodies

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Daratumumab – Darzalex®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Daratumumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Daratumumab | 945721-28-8 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 25 May 2017

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity published in 1999, well before the availability of most monoclonal antibody therapies).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive drugs; mentions that "the biological immunosuppressants are largely free from hepatotoxicity, with the exception of the TNF alpha antagonists").
Chabner BA, Barnes J, Neal J, Olson E, Mujagiv H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-53. (Textbook of pharmacology and therapeutics).
Lokhorst HM, Plesner T, Laubach JP, Nahi H, Gimsing P, Hansson M, Minnema MC, et al. Targeting CD38 with daratumumab monotherapy in multiple myeloma. N Engl J Med 2015; 373: 1207-19. (Among 72 patients with refractory multiple myeloma treated with daratumumab [8 vs 16 mg/kg] for up to 24 months, the overall response rate was 25%, and side effects were frequent, with serious adverse events in 40% vs 33%; no mention of ALT elevations or hepatotoxicity). 26308596
Usmani SZ, Weiss BM, Plesner T, Bahlis NJ, Belch A, Lonial S, Lokhorst HM, et al. Clinical efficacy of daratumumab monotherapy in patients with heavily pretreated relapsed or refractory multiple myeloma. Blood 2016; 128: 37-44. (Among 148 patients with refractory multiple myeloma treated with daratumumab, the overall response rate was 31% and adverse events included fatigue [42%], nausea [30%], anemia [28%], back pain [27%], cough [26%], thrombocytopenia [22%] and neutropenia [21%]; no mention of ALT elevations or hepatotoxicity). 27216216
Plesner T, Arkenau HT, Gimsing P, Krejcik J, Lemech C, Minnema MC, Lassen U, et al. Phase 1/2 study of daratumumab, lenalidomide, and dexamethasone for relapsed multiple myeloma. Blood 2016; 128 (14): 1821-8. (Phase 1 studies of daratumumab identified no dose limiting toxicities, and phase 2 studies showed that common side effects included neutropenia, thrombocytopenia, cough, diarrhea and fatigue; ALT elevations above 5 times ULN occurred in 1 patient who was also taking lenalidomide and the abnormalities resolved with its dose adjustment). 27531679
Dimopoulos MA, Oriol A, Nahi H, San-Miguel J, Bahlis NJ, Usmani SZ, Rabin N, et al.; POLLUX Investigators. Daratumumab, lenalidomide, and dexamethasone for multiple myeloma. N Engl J Med 2016; 375: 1319-31. (Among 569 patients with previously treated multiple myeloma treated with lenalidomide and dexamethasone, progression-free survival was prolonged by addition of daratumumab [83% vs 60% at one year], while side effects were more common and included neutropenia, diarrhea, upper respiratory infection and cough; no mention of ALT elevations or hepatotoxicity). 27705267
Palumbo A, Chanan-Khan A, Weisel K, Nooka AK, Masszi T, Beksac M, Spicka I, et al.; CASTOR Investigators. Daratumumab, bortezomib, and dexamethasone for multiple myeloma. N Engl J Med 2016; 375: 754-66. (Among 498 patients with relapsed or refractory multiple myeloma treated with bortezomib and dexamethasone, progression-free survival was increased by the addition of daratumumab [61% vs 27%], and side effects were also greater including thrombocytopenia, neutropenia, peripheral neuropathy, diarrhea, cough and dyspnea; no mention of ALT elevations or hepatotoxicity). 27557302
Lonial S, Weiss BM, Usmani SZ, Singhal S, Chari A, Bahlis NJ, Belch A, et al. Daratumumab monotherapy in patients with treatment-refractory multiple myeloma (SIRIUS): an open-label, randomised, phase 2 trial. Lancet 2016; 387 (10027): 1551-60. (Among 106 patients with refractory multiple myeloma treated with daratumumab, the overall response rate was 29% and adverse events included neutropenia, diarrhea, fatigue, nausea, anemia, thrombocytopenia, back pain and cough; no mention of ALT elevations or hepatotoxicity). 26778538
Rajkumar SV. Daratumumab in multiple myeloma. Lancet 2016; 387 (10027): 1490-2. (Editorial in response to Lonial [2016] pointing out the improving results of chemotherapy of multiple myeloma, particularly with using combinations of 2 or 3 agents). 26778537
Three new drugs for multiple myeloma. Med Lett Drugs Ther 2016; 58 (1495): e70-1. (Concise review of three agents that had been recently approved for use in multiple myeloma including daratumumab; no mention of ALT elevations or hepatotoxicity). 27192621
Brioli A, Mügge LO, Hochhaus A, Von Lilienfeld-Toal M. Safety issues and management of toxicities associated with new treatments for multiple myeloma. Expert Rev Hematol 2017; 10: 193-205. (Review of adverse events from new treatments of multiple myeloma and their management; does not specifically discuss hepatotoxicity). 28116920
Kapoor P, Rajkumar SV. Multiple myeloma in 2016: Fresh perspectives on treatment and moments of clarity. Nat Rev Clin Oncol 2017; 14: 73-4. (Review of new agents for therapy of multiple myeloma, focusing upon the advantages of triple therapy). 28071678

## OTHER REFERENCE LINKS

1. Recent References on Daratumumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Daratumumab/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D))
2. Trials on Daratumumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Daratumumab)